# Eptinezumab

## OVERVIEW

### Introduction

Eptinezumab is a humanized monoclonal antibody to calcitonin gene like peptide (CGLP) which is used in the prevention of migraine headaches. Eptinezumab is generally well tolerated and has not been associated with serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Eptinezumab (ep” ti nez’ ue mab) is a humanized IgG1 monoclonal antibody directed against the calcitonin gene-related peptide (CGRP) which plays an important role in the pathogenesis of migraine headaches. CGRP is a potent vasodilator and pain neurotransmitter, infusions of which can induce migraine headache in susceptible persons and serum levels of which are elevated in persons with migraine headaches. Eptinezumab binds to circulating and tissue expressed CGRP and prevents its binding to its receptor on vascular and neural tissue. In preregistration randomized, placebo controlled trials, eptinezumab given every 12 weeks reduced the frequency of migraines in patients with episodic migraine (<15 days of headaches monthly) and chronic migraine (≥15 days of headache monthly) by 25% to 35% compared to placebo infusions. Eptinezumab was approved in the United States in 2019 for prevention of migraine headaches in adults with frequent or severe migraines. Eptinezumab is available in single use vials of 100 mg in 1 mL under the brand name Vyepti. The recommended dose is 100 mg infused over 30 minutes every 3 months. Common side effects of eptinezumab include local injection reactions, nasopharyngitis, dizziness, headaches and fatigue. Also reported have been uncommon and generally mild-to-moderate instances of hypersensitivity reactions including angioedema.

### Hepatotoxicity

In prelicensure randomized controlled trials, only rare instances of mild-to-moderate serum aminotransferase elevations were reported in patients receiving intravenous eptinezumab and all were transient, asymptomatic and did not necessitate discontinuation of eptinezumab infusions. Furthermore, there were no reported instances clinically apparent liver injury or severe hepatic adverse events attributed to the monoclonal antibody. Since approval and more general use of eptinezumab there have been no reports of clinically significant liver injury attributed to its use.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Possible mechanisms of liver injury due to eptinezumab are not known. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence that inhibition of CGRP signaling is harmful to the liver.

Drug Class: Monoclonal Antibodies, Migraine Headache Agents

Drugs in the Subclass, CGRP Antagonists: Erenumab, Fremanezumab, Galcanezumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eptinezumab – Vyepti®

DRUG CLASS

Migraine Headache Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eptinezumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Eptinezumab | 1644539-04-7 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 09 July 2021

Abbreviations: CGRP, calcitonin gene-related peptide.
Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of eptinezumab).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761119Orig1s000SumR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the eptinezumab application which mentions safety results in Section 8, page 16).
Dodick DW, Lipton RB, Silberstein S, Goadsby PJ, Biondi D, Hirman J, Cady R, et al. (2019). Eptinezumab for prevention of chronic migraine: A randomized phase 2b clinical trial. Cephalalgia. (Among 616 adults with chronic migraine treated with eptinezumab [10, 30, 100 or 300 mg] or placebo as a single intravenous infusion, a 75% reduction in number of migraine days per month occurred in 27%, 28%, 31% and 33% on drug vs 21% on placebo, and adverse events were mostly mild upper respiratory symptoms and dizziness; there were no serious adverse events and data on ALT levels were not reported).
Ashina M, Saper J, Cady R, Schaeffler BA, Biondi DM, Hirman J, Pederson S, et al. (2020). Eptinezumab in episodic migraine: A randomized, double-blind, placebo-controlled study (PROMISE-1). Cephalalgia. (Among 888 patients with episodic migraine treated with eptinezumab [30, 100 or 300 mg] vs placebo intravenously every 12 weeks for 48 weeks, the reduction in number of migraine days per month averaged -4.0, -3.9, -4.2 on drug vs -3.2 on placebo, and adverse events that were more frequent with drug were upper respiratory symptoms and fatigue; no mention of ALT elevations or hepatotoxicity).
Lipton RB, Goadsby PJ, Smith J, Schaeffler BA, Biondi DM, Hirman J, Pederson S, et al. (2020). Efficacy and safety of eptinezumab in patients with chronic migraine: PROMISE-2. Neurology. (Among 1072 patients with chronic migraine treated with eptinezumab [100 or 300 mg] vs placebo intravenously at week 0 and 12, average number of migraine days per month decreased by 7.7 and 8.2 with eptinezumab and by 5.6 days with placebo, and adverse events were uncommon and usually mild, the most frequent being nasopharyngitis [9.4% vs 6%] and fatigue [1.8% vs <1%], and there were no hepatic adverse events and no mention of ALT elevations).
Dhillon S. (2020). Eptinezumab: first approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy and safety of eptinezumab shortly after its approval for use in the US, mentions side effects of fatigue and dizziness, but does not mention ALT elevations or hepatotoxicity).
(2020). Eptinezumab (Vyepti) for migraine prevention. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of eptinezumab in relation to other drugs for migraine prevention shortly after its approval in the US, states that it is modestly effective and that adverse events include nasopharyngitis and hypersensitivity reactions [1-2%] including angioedema; no mention of ALT elevations or hepatotoxicity).
Drugs for Migraine. (2020). Med Lett Drugs Ther. (Concise summary of the relative clinical efficacy, safety and costs of drugs to treat acute migraine headache [such as analgesics, opiates, triptans and ergots] and to prevent migraines [such as anticonvulsants, beta blockers, antidepressants and CGRP antagonists]).
Silberstein S, Diamond M, Hindiyeh NA, Biondi DM, Cady R, Hirman J, Allan B, et al. (2020). Eptinezumab for the prevention of chronic migraine: efficacy and safety through 24 weeks of treatment in the phase 3 PROMISE-2 (Prevention of migraine via intravenous ALD403 safety and efficacy-2) study. J Headache Pain. (Among 1072 adults with chronic migraine treated with eptinezumab [100 or 300 mg] vs placebo intravenously at 0 and 12 weeks, the reduction in days with migraine per month decreased by week 24 by 8.2 and 8.8 days vs 6.2 days with placebo, and no new adverse events were reported compared to [compared to Lipton 2020], hypersensitivity reactions occurring in 3 patients [0.9%] with the second dose; no mention of ALT elevations or hepatotoxicity).
Smith TR, Janelidze M, Chakhava G, Cady R, Hirman J, Allan B, Pederson S, et al. (2020). Eptinezumab for the prevention of episodic migraine: sustained effect through 1 year of treatment in the PROMISE-1 Study. Clin Ther. (Among 888 patients with episodic migraine treated with eptinezumab [30, 100, 300 mg] vs placebo intravenously every 12 weeks for up to one year, reductions in average number of days with migraine per month were 4 to 4.8 with eptinezumab vs 3.2 to 4.6 with placebo, and adverse events rates were similar in all groups and decreased after the initial dose, and “no serious tolerability signals were observed”).
Kudrow D, Cady RK, Allan B, Pederson SM, Hirman J, Mehta LR, Schaeffler BA. (2021). Long-term safety and tolerability of eptinezumab in patients with chronic migraine: a 2-year, open-label, phase 3 trial. BMC Neurol. (Among 128 adults with chronic migraine treated with eptinezumab [300 mg] intravenously every 12 weeks for up to 2 years, adverse events included upper respiratory tract symptoms and a low rate of hypersensitivity reactions [5 patients], one of which was moderate and responded rapidly to an infusion of antihistamine; in addition, “No clinically relevant trends in clinical laboratory….results were identified”).
Smith TR, Spierings ELH, Cady R, Hirman J, Schaeffler B, Shen V, Sperling B, et al. (2021). Safety and tolerability of eptinezumab in patients with migraine: a pooled analysis of 5 clinical trials. J Headache Pain. (Analysis of safety based upon pooled results from five placebo controlled trials of eptinezumab in 2867 patients with migraine found an overall treatment-emergent adverse event ate of 55% [1.7% severe] with drug vs 52% [1.4% severe] with placebo, and most events were considered unrelated, although infusion related hypersensitivity reactions occurred in 1.1% of eptinezumab vs 0% of placebo recipients).
Winner PK, McAllister P, Chakhava G, Ailani J, Ettrup A, Krog Josiassen M, Lindsten A, et al. (2021). Effects of intravenous eptinezumab vs placebo on headache pain and most bothersome symptom when initiated during a migraine attack: a randomized clinical trial. JAMA. (Among 476 adults who were treated with an intravenous infusion within 1 to 6 hours of onset of a migraine headache, the time to being pain free was shorter with 100 mg of eptinezumab than placebo [4 vs 9 hours] and adverse event rates were similar except for hypersensitivity reactions [2.1% vs none]; no mention of hepatic adverse events or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Eptinezumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Eptinezumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Eptinezumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eptinezumab)